# Doxycycline

## OVERVIEW

### Introduction

Doxycycline is a commonly used, semisynthetic tetracycline antibiotic used to treat infections due to susceptible bacteria, rickettsia, spirochetes, chlamydia, and mycoplasma. Doxycycline has been linked to rare instances of acute liver injury that can be prolonged and severe.

### Background

Doxycycline (dox" i sye' kleen) is a semisynthetic tetracycline that is used for mild-to-moderate infections due to susceptible organisms. Doxycycline, like other tetracyclines, is active against a wide spectrum of gram-positive and gram-negative bacteria as well as against several rickettsia, spirochetes, chlamydia and mycoplasma. Unlike tetracycline and oxytetracycline, doxycycline has excellent oral availability and wide tissue penetration. Indications include upper respiratory, skin, or soft tissue infections due to susceptible bacteria, gonorrhea and syphilis in penicillin-allergic patients, non-gonococcal urethritis, acute pelvic inflammatory disease, epididymitis, orchitis, Lyme disease, and as prophylaxis against traveler’s diarrhea. Doxycycline is also used chronically as treatment of acne. Doxycycline was approved for use in the United States in 1967 and is still widely used, with more than 9 million prescriptions filled yearly. Doxycycline is available in multiple generic forms in capsules and tablets ranging from 20 to 100 mg, and as oral suspensions for pediatric use. Typical adult doses are 100 to 200 mg twice daily for 7 to 30 days. Parenteral forms for intravenous or intramuscular administration are also available. Trade names for doxycycline include Vibramycin, Oracea, Adoxa, Monodox and Doxycin. Common side effects include headache, dizziness, nausea, gastrointestinal upset, photosensitivity, skin and tooth discoloration, and rash. Rare but potentially severe adverse events include hypersensitivity reactions, permanent discoloration of teeth, Clostridia difficile associated diarrhea, autoimmune conditions, pseudotumor cerebri, and hepatotoxicity.

### Hepatotoxicity

Doxycycline has been associated with rare instances of hepatic injury, the incidence being estimated to be between 1:16,000 to 1:50,000 cases per person exposed. Symptoms of doxycycline induced liver injury typically arise within a few days to several weeks of starting therapy. Dramatically short latencies to onset of symptoms (1 to 4 days) occur largely in persons with a history of previous exposure, either with or without injury. The pattern of enzyme elevation ranges from hepatocellular to cholestatic and is probably most commonly mixed. The onset is often abrupt and can be accompanied by signs of hypersensitivity, such as fever, rash, and eosinophilia (DRESS syndrome). Recovery is usually rapid and complete within 4 to 6 weeks. However, instances of severe and prolonged cholestatic liver injury have been reported with oral doxycycline including cases with vanishing bile duct syndrome. The autoimmune-like hepatitis that is typical of minocycline liver injury has not been linked to doxycycline, despite similarities in chemical structure and similar indications and uses of the two drugs. This difference may be due to the short duration of therapy with doxycycline for 7 or 10 days as opposed to the frequent use of minocycline for months or years. High dose intravenous doxycycline can cause acute fatty liver like that caused by intravenous tetracycline, particularly in susceptible patients such as pregnant women. This type of injury is, however, quite rare. Nevertheless, for these reasons, the duration and dose of parenteral doxycycline therapy should be minimized.

Likelihood score: B (highly likely but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the idiosyncratic liver injury associated with doxycycline is unknown, but several features (short latency, recurrence with reexposure) suggest an immunoallergic etiology. The injury is similar to the short-latency hepatitis caused by minocycline which has been linked to HLA-B*35:02, although only in a minority of cases (16%).

### Outcome and Management

Recovery after withdrawal of doxycycline is usually rapid, but in instances with severe cholestasis, can require 2 to 6 months. No convincing case of acute liver failure due to oral doxycycline has been published, but rare instances of vanishing bile duct syndrome have. Cross sensitivity to hepatic injury between minocycline and doxycycline has not been shown, but both can cause a short incubation period acute hepatitis with immunoallergic features, so that some degree of cross reactivity may occur.

Drug Class: Antiinfective Agents, Tetracyclines

## CASE REPORT

### Case 1. Cholestatic hepatitis attributed to doxycycline therapy.(1)

A 32 year old man with fever and cough was treated with doxycycline for suspected pneumonitis and developed skin rash, abdominal pain and dark urine one day later. Symptoms of fatigue, nausea and pruritus arose and doxycycline was stopped after 8 days of therapy. His serum enzymes were elevated and he was mildly jaundiced with a total bilirubin of 4.4 mg/dL (Table). He also had eosinophilia (13.5%). He tested negative for antibodies to hepatitis A, B, and C as well as markers of acute CMV and Epstein Barr infection. Autoantibodies were negative, and an abdominal ultrasound was normal. He remained jaundiced for several months and underwent a liver biopsy that showed intrahepatic cholestasis with mild inflammatory changes suggestive of drug induced liver injury. In follow-up at 3 and again at 18 months, all liver tests had returned to normal.

#### Key Points

Medication: | Doxycycline (200 mg once daily for 8 days)
Pattern: | Mixed (R=3.9), later hepatocellular (R=10)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 1 day to symptoms, 8 days to jaundice
Recovery: | 3 months
Other medications: | None mentioned

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* | Alk P* | Bilirubin* | Comment
Doxycycline given for 8 days for suspected pneumonia
1 day | 0 | NA | NA | NA | Rash and nausea
8 days | 0 | 173 | 130 | 4.4 | Doxycycline stopped
11 days | 3 days | 194 | 112 | 5.0 | Negative viral markers
36 days | 28 days | 431 | 104 | 8.1
53 days | 45 days | 442 | 91 | 7.1 | Liver biopsy
56 days | 48 days | 474 | 104 | 7.2
2 months | 2 months | 743 | 100 | 4.6
3 months | 3 months | 388 | 87 | 3.1
4 months | 4 months | 32 | 61 | 0.8
Normal Values | | <40 | <115 | <1.2

ata estimated from Figure 1 and converted from µkat/l and µmol/L.

#### Comment

A convincing history, presentation, biochemical pattern and course for drug induced liver disease with a rapid onset, mixed followed by hepatocellular pattern of enzyme elevations and fairly prolonged jaundice. The only medication taken was doxycycline, which the patient had received at least twice in the past. The short latency to onset suggests previous sensitization. Recovery was slow but complete. Thus, the overall presentation is quite convincing as immunoallergic drug induced liver injury due to doxycycline. Future exposures to doxycycline as well as other tetracyclines should be avoided.

### Case 2. Cholestatic hepatitis attributed to doxycycline.(2)

A 43 year old woman developed nausea and fatigue 3 days after starting doxycycline (100 mg twice daily) for acne. She stopped the antibiotic but continued to have nausea and fatigue and over the next 10 days developed pruritus, dark urine and then jaundice. She denied a history of liver disease, risk factor for viral hepatitis, and drug allergies and drank alcohol infrequently. She had no concurrent medical conditions except for obesity and hyperlipidemia and was taking no other medications, herbal products, or nutritional supplements. On examination, she was jaundiced and had mild right upper quadrant tenderness. Her BMI was 33.7 kg/m^2^. Laboratory test results included a total bilirubin of 12.5 mg/dL, ALT 83 U/L, AST 95 U/L, alkaline phosphatase 339 U/L (R value < 1: cholestatic) , and INR 1.1 (Table). She tested negative for markers of hepatitis A, B, and C as well as markers of acute CMV and Epstein Barr infection. Autoantibodies were negative, and an abdominal ultrasound was normal except for a large gallstone. Subsequently, magnetic resonance cholangiopancreatography demonstrated normal intra- and extra-hepatic bile ducts and no evidence of biliary obstruction. A liver biopsy showed intrahepatic cholestasis with mild inflammatory changes suggestive of drug induced liver injury. She recovered slowly, jaundice cleared by 1 to 2 months, and in follow-up at 4 and 5 months, all liver tests had returned to normal.

#### Key Points

Medication: | Doxycycline (100 mg twice daily for 3 days)
Pattern: | Cholestatic (R < 1.0)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 3 days to symptoms, 13 days to jaundice
Recovery: | 4 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT | Alk P | Bilirubin | Comment
Doxycycline prescribed for acne and stopped after 3 days because of side effects
3 days | 0 | NA | NA | NA | Fatigue and nausea
13 days | 10 days | 83 | 339 | 12.5 | Dark urine and jaundice
14 days | 11 days | 80 | 325 | 11.2 | MRCP
17 days | 14 days | 50 | 365 | 12.4 | Liver Biopsy
3 weeks | 16 days | 48 | 380 | 11.5
1 month | 18 days | 50 | 355 | 10.5 | Discharged
| 1 month | 80 | 175 | 2.0
| 3 months | 30 | 140 | 0.5
| 4 months | 45 | 120 | 0.7
6 months | 5 months | 20 | 95 | 0.8 | Final Follow up
Normal Values | | <50 | <130 | <1.3

* Values estimated from Figure 3.

#### Comment

A striking but very convincing course for drug induced liver disease due to doxycycline with a rapid onset, cholestatic pattern of enzyme elevations, and slightly prolonged jaundice. The only medication taken was doxycycline which is uncommon but helpful in the assignment of causality to doxycycline. The short latency to onset suggests previous sensitization. Recovery was complete. Thus, the overall presentation is quite convincing as immunoallergic drug induced liver injury due to doxycycline. Future exposure to doxycycline as well as other tetracyclines should be avoided.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Doxycycline – Generic, Monodox®, Vibramycin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=doxycycline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Doxycycline Monohydrate | 17086-28-1 | C22-H24-N2-O8

## CITED REFERENCES

1 Björnsson E, Lindberg J, Olsson R. Liver reactions to oral low-dose tetracyclines. Scand J Gastroenterol 1997; 32: 390-5.9140164
2 Varma S, Nathanson J, Dowlatshahi M, Del Portillo A, Ramirez I, Garcia-Carrasquillo R. Doxycycline-induced cholestatic liver injury. Clin J Gastroenterol. 2021;14:1503-1510..34228348

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2026

Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high dose of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury).
MacDougall C, Chambers HF. Tetracyclines and glycylcyclines. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Chabner KA, Knollman KC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1521-6. (Textbook of pharmacology and therapeutics).
Wruble LD, Ladman AJ, Britt LG, Cummins AJ. Hepatotoxicity produced by tetracycline overdosage. JAMA 1965; 192: 6-8. (56 year old woman with cecal volvulus developed jaundice [bilirubin 7.8 mg/dL, AST 98 U/L, Alk P normal] 2 days after receiving 8 g of tetracycline, subsequently progressing to liver failure and death; autopsy showed fatty liver). 14262279
Tetracyclines and the liver in pregnancy. Lancet 1966; 1: 357-8. (Editorial on the history of acute fatty liver of pregnancy, first described by Sheehan in 1940 and later linked to high dose iv tetracycline in pregnancy, but also in nonpregnant women and in men). 4159865
Wenk RE, Gebhardt FC, Bhagavan BS, Lustgarten JA, McCarthy EF. Tetracycline-associated fatty liver of pregnancy, including possible pregnancy risk after chronic dermatologic use of tetracycline. J Reprod Med 1981; 26: 135-41. (Two cases of acute fatty liver over a 15 year period and 60,000 deliveries; one woman received tetracycline for 3 days, the second had no history of its use, but had tetracycline detected in bony tissue suggestive of chronic use). 7230149
Böcker R, Estler CJ, Müller S, Pfandzelter C, Spachmüller B. Comparative evaluation of the effects of tetracycline, rolitetracycline and doxycycline on some blood parameters related to liver function. Arzneimittelforschung 1982; 32: 237-41. (Minocycline caused a dose dependent rise in AST and increase in triglycerides, but no hepatic histological changes in mice; similar findings were previously reported with tetracycline). 7200783
Schrumpf E, Nordgard K. Unusual cholestatic hepatotoxicity of doxycycline in a young male? Scand J Gastroenterol 1986; 21 (Suppl 120): 68. Not in PubMed (Abstract: Patient developed severe and prolonged cholestatic hepatitis after 2 weeks of oral doxycycline [bilirubin 9.8 rising to 69.5 mg/L, ALT 53 to 132 U/L, Alk P 283 to 775 U/L] and severe itching; ultimate recovery after 6 months).
Lienart F, Morissens M, Jacobs P, Ducobu J. Doxycycline and hepatotoxicity. Acta Clin Belg 1992; 47: 205-8. (42 year old woman with severe cardiomyopathy developed encephalopathy and enzyme elevations with jaundice after 5 days of oral doxycycline [bilirubin 1.2 mg/dL, ALT 139 U/L, Alk P 373 U/L, ammonia 99 mcg/dL], resolving rapidly on stopping; likely due to heart failure and ischemia rather than drug induced liver injury). 1332350
Carson JL, Strom BL, Duff A, et al. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119 (7 Pt 1): 576-83. (Case control study using Medicaid billing results between 1980-87 found 107 cases of hospitalization for unexplained hepatitis, odds ratios for erythromycin 5.2; sulfonamides 11.4; tetracyclines 5.2; total of 5 cases exposed to tetracycline, doxycycline or minocycline). 8363168
Hunt CM, Washington K. Tetracycline-induced bile duct paucity and prolonged cholestasis. Gastroenterology 1994; 107: 1844-7. (Two cases of severe and prolonged cholestatic hepatitis and bile duct paucity after oral tetracyclines; 37 year old woman developed jaundice 2 days after 3 day course of doxycycline with prolonged cholestasis [peak bilirubin 30 mg/dL], but ultimate recovery; 63 year old woman developed jaundice 6 weeks after a 2 week course of tetracycline [bilirubin 11.8 mg/dL, ALT 245 U/L], with prolonged jaundice [peak bilirubin 29.5 mg/dL) and persistence of enzyme elevations for >3 years [Alk P 631 U/L, ALT 97 U/L]). 7958700
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports between 1978 and 1987 in Denmark; no tetracycline is mentioned as a cause). 1506809
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; triacetyloleandomycin accounted for 21 cases [2.1%] and minocycline for at least 4). 8816722
Tham SN, Kwok YK, Chan HL. Cross-reactivity in fixed drug eruptions to tetracyclines. Arch Dermatol 1996; 132: 1134-5. (Among 9 Chinese patients with a fixed drug eruption due to tetracycline, all had recurrence on doxycycline and 3 on minocycline; no mention of liver involvement). 8795565
Björnsson E, Lindberg J, Olsson R. Liver reactions to oral low-dose tetracyclines. Scand J Gastroenterol 1997; 32: 390-5. Review. PMID: 9140164 (32 year old man developed abdominal pain, dark urine and rash within 24 hours of starting doxycycline which he had received in the past [bilirubin 4.3- 8.1 mg/dL, ALT 3.5 times ULN, Alk P 1.1 times ULN], resolving within 3 months of stopping; thorough review of all published and SADRAC reported cases of oral tetracycline associated liver injury found 15 cases, only 6 rated as likely, none with tetracycline, 5 doxycycline, 1 lymecycline).
Shapiro LE, Knowles SR, Shear NH. Comparative safety of tetracycline, minocycline, and doxycycline. Arch Dermatol 1997; 133: 1224-30. (Review of toxicity of tetracyclines from literature and a Canadian database; minocycline had the highest rates of adverse events, but all were relatively safe: no lupus-like syndrome associated with doxycycline or tetracycline). 9382560
Westermann GW, Böhm M, Bonsmann G, Rahn KH, Kisters K. Chronic intoxication by doxycycline use for more than 12 years. J Intern Med 1999; 246: 591-2. (38 year old man took large doses of doxycycline chronically and developed repeated bouts of mild jaundice [bilirubin 3.4-5.0 mg/dL, ALT 44-118 U/L, Alk P 466 U/L] and weakness, skin discoloration and heart block, resolving upon stopping). 10620103
Sturkenboom MC, Meier CR, Jick H, Stricker BH. Minocycline and lupus like syndrome in acne patients. Arch Intern Med 1999; 159: 493-7. (Case control study in 27,688 acne patients in UK database, risk of lupus increased 8.5 fold in minocycline treated patients, not with other tetracyclines, typically long term therapy; liver involvement not mentioned; more common in women, absolute risk low). 10074958
Firouzmand M, Zafrani ES, Dhumeaux D, Mallat A. [Microvesicular steatosis after administration of therapeutic doses of doxycycline] Gastroenterol Clin Biol 2002; 26: 1176-7. French. PMID: 12520208 (65 year old woman with alcoholic liver disease developed jaundice and mild increases in ALT and Alk P when given 1 month course of doxycycline; liver biopsy showed fat, much was microvesicular, but patient was also on floxacillin, rifampin and recently received ampicillin and gentamicin for osteomyelitis).
Selimoglu MA, Ertekin V. Autoimmune hepatitis triggered by Brucella infection or doxycycline or both. Int J Clin Pract 2003; 57: 639-41. (11 year old girl was found to have abnormal liver tests 3 weeks after finishing a 6 week course of doxycycline for acute brucellosis [bilirubin 1.2 mg/dL, ALT 222 U/L, Alk P 561 U/L, ANA negative, HLA B8 DRB1*03], a liver biopsy showing inflammation, necrosis and bridging fibrosis, improving on prednisone therapy, relapsing on stopping and ultimately requiring long term azathioprine therapy). 14529072
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, none of which were attributed to minocycline, doxycycline or tetracycline). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, one case was attributed to doxycycline, but no other tetracycline mentioned). 16165719
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish Registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network found 461 cases of drug induced liver disease; no tetracycline was listed among the top 20 agents implicated [at least 5 cases]). 16083708
Smith K, Leyden JJ. Safety of doxycycline and minocycline: a systematic review. Clin Ther 2005; 27: 1329-42. (Systematic review of overall safety of doxycycline and minocycline stressing overall low rate of adverse events [13-72 per million prescriptions]; little mention of liver toxicity). 16291409
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; the list of most 21 most commonly implicated drugs did not include a tetracycline). 16054882
Margolis DJ, Hoffstad O, Bilker W. Association or lack of association between tetracycline class antibiotics used for acne vulgaris and lupus erythematosus. Br J Dermatol 2007; 157: 540-6. (Analysis of UK database on 97,694 subjects with acne, 25% received minocycline, 16% doxycycline and 45% other tetracyclines. Hazard ratio for lupus-like syndrome was 3.11 for minocycline; no increased risk or association with doxycycline or other tetracyclines). 17596147
Heaton PC, Fenwick SR, Brewer DE. Association between tetracycline or doxycycline and hepatotoxicity: a population based case-control study. J Clin Pharm Ther 2007; 32: 483-7. (Analysis of 2 years of Medicaid claims in California found 3377 cases of “hepatotoxicity”; 20 had received tetracycline <45 days before onset; only 4 controls had: adjusted odds ratio 3.7; not elevated for doxycycline; this despite safety record of oral tetracyclines and known hepatotoxicity of doxycycline). 17875115
Meropol SB, Chan KA, Chen Z, Finkelstein JA, Hennessy S, Lautenbach E, Platt R, et al. Adverse events associated with prolonged antibiotic use. Pharmacoepidemiol Drug Saf 2008 17: 423-32. (Analysis of 3 large UK and US databases on medication use and clinical outcomes covering ~6 million patients for adverse events related to >1 month of either amoxicillin [0-1.2/100,000], ciprofloxacin [0-5.7/100,000] and doxycycline [0-0.9/100,000 person days], but no mention of liver toxicities). 18383065
Carrascosa MF, Lucena MI, Andrade RJ, Caviedes JRS, et al. Fatal acute hepatitis after sequential treatment with levofloxacin, doxycycline, and naproxen in a patient presenting with acute Mycoplasma pneumoniae infection. Clin Ther 2009; 31: 1014-19. (63 year old man developed acute liver injury 1 week after starting a 3 day course of levofloxacin and 5 days after starting doxycycline [bilirubin 4.0 rising to >35 mg/dL, ALT 1577 U/L, Alk P 189 U/L], with subsequent progressive liver failure and death; biopsy showed massive necrosis). 19539102
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, minocycline accounted for 3 cases, doxycycline for 3 cases and tetracycline was listed as a secondary possible cause for one). 18955056
Chavant F, Lafay-Chebassier C, Beauchant M, Perault-Pochat MC. [Doxycycline induced hepatitis]. Gastroenterol Clin Biol 2008; 32: 825-7. French. PMID: 18823729 (37 year old man developed fatigue 6 weeks after starting doxycycline [bilirubin 2.8 mg/dL, ALT 2322 U/L, Alk P 184 U/L, ANA 1:100], resolving within 6 weeks of stopping).
Robles DT, Leonard JL, Compton N, Waghmare A, McDonough KA, George E, Wolgamot G, Fleckman P. Severe drug hypersensitivity reaction in a young woman treated with doxycycline. Dermatology 2008; 217: 23-6. (20 year old woman developed severe rash and fever 3 weeks after starting doxycycline for acne [bilirubin 2.5 mg/dL, ALT 133 U/L, Alk P 205 U/L, eosinophils 980/µL], requiring intubation and corticosteroid therapy and 3 week hospitalization, ultimately resolving). 18332631
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database containing 9036 hepatic adverse drug reactions in children includes 117 cases attributed to minocycline, but no other tetracycline listed in the top 40 causes). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were due to tetracyclines). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, including 15 to isoniazid alone [ranking first], 6 to isoniazid combined with other agents, 3 to rifampin and pyrazinamide, and 1 to dapsone). 20949552
Björnsson E, Talwalkar J, Treeprasertsuk S, Kamath PS, Takahashi N, Sanderson S, Neuhauser M, Lindor K. Drug-induced autoimmune hepatitis: clinical characteristics and prognosis. Hepatology 2010; 51: 2040-8. (Among 261 cases of autoimmune hepatitis seen at the Mayo Clinic between 1997 and 2007, 24 were attributed to drugs, 11 to minocycline, 11 to nitrofurantoin and 2 to others; all responded to corticosteroid therapy and all who were withdrawn did not relapse). 20512992
Mailhol C, Tremeau-Martinage C, Paul C, Godel A, Lamant L, Giordano-Labadie F. [Severe drug hypersensitivity reaction (DRESS syndrome) to doxycycline]. Ann Dermatol Venereol 2010; 137: 40-3. French. PMID: 20110067 (59 year old woman developed fever, rash and facial edema 3 weeks after starting doxycycline for malaria prophylaxis [bilirubin normal, ALT 278 U/L, eosinophils 15%, atypical lymphocytosis], resolving on discontinuation).
Leitner JM, Graninger W, Thalhammer F. Hepatotoxicity of antibacterials: Pathomechanisms and clinical. Infection 2010; 38: 3-11. (Review of hepatotoxicity of antibiotics; mentions that hepatotoxicity from oral tetracycline is rare ~1.5 cases per million prescriptions, whereas minocycline has been associated with either an immediate reaction with eosinophilia, dermatitis and enzyme elevations or a delayed autoimmune hepatitis-like syndrome). 20107858
Glenn C, Feldman SR. Letter: Tetracycline-induced hepatotoxicity. Dermatol Online J 2011; 17: 14. (49 year old woman developed fatigue, edema, low albumin and raised alkaline phosphatase levels [bilirubin and ALT normal] 6 months after starting oral tetracycline for rosacea, albumin and alkaline phosphatase levels returning to normal upon stopping, later tolerating doxycycline). 22233750
Czaja AJ. Drug-induced autoimmune-like hepatitis. Dig Dis Sci 2011; 56: 958-76.21327704
(Review of drug induced autoimmune hepatitis-like syndromes, most commonly caused by nitrofurantoin and minocycline, but also with hydralazine, methyldopa and more rarely with statins, fibrates, NSAIDs, various herbals and tumor necrosis factor antagonists) .
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 2 of which were attributed to doxycycline yielding an estimated incidence of 1 per 16,400 persons exposed). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 37 of which were attributed to an antibiotic, but none to a tetracycline). 24552865
Douros A, Bronder E, Andersohn F, Klimpel A, Thomae M, Sarganas G, Kreutz R, et al. Drug-induced liver injury: results from the hospital-based Berlin Case-Control Surveillance Study. Br J Clin Pharmacol 2015; 79: 988-99. (Among 76 inpatients with hepatitis of unknown cause enrolled in a prospective case-cohort surveillance study between 2002 and 2011, one was attributed to doxycycline, but no other tetracycline was implicated). 25444550
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 28 [3%] to minocycline and 4 [0.4%] to doxycycline). 25754159
Tang DM, Koh C, Twaddell WS, von Rosenvinge EC, Han H. Acute hepatocellular drug-induced liver injury from bupropion and doxycycline. ACG Case Rep J 2015; 3: 66-8. 26504884 (29 year old African American man developed jaundice 14 days after starting bupropion and doxycycline [bilirubin 19.9 mg/dL, ALT 888 U/L, Alk P 234 U/L, INR 3.0, eosinophils 5%] with resolution within 2 months on prednisone, the authors suggesting that bupropion was the most likely cause).
Urban TJ, Nicoletti P, Chalasani N, Serrano J, Stolz A, Daly AK, Aithal GP, et al; Drug-Induced Liver Injury Network (DILIN); Pharmacogenetics of Drug-Induced Liver Injury group (DILIGEN); International Serious Adverse Events Consortium (iSAEC). Minocycline hepatotoxicity: clinical characterization and identification of HLA-B*35:02 as a risk factor. J Hepatol 2017; 67: 137-44. (The uncommon HLA allele B*35:02 was found in 4 of 25 [16%] of patients with minocycline hepatotoxicity vs 0.6% in a population control group; those with and without this allele did not different in clinical features or outcome). 28323125
Tuohutaerbieke M, Li X, Yin Y, Chen W, Wu D, Mao Z, Mamuerjiang J, et al. The characteristics, prevalence, and risk factors of drug-induced liver injury among brucellosis inpatients in Xinjiang, China. Front Pharmacol. 2021;12:657805. (Among 783 patients hospitalized for therapy of brucellosis between 2015 and 2019 in a Chinese referral center, 71 developed evidence of drug-induced liver injury, most receiving multiple agents, all 71 getting rifampin, 54 doxycycline, 36% nimesulide, and 20% levofloxacin; no specific results given). PMID: 34040524
Varma S, Nathanson J, Dowlatshahi M, Del Portillo A, Ramirez I, Garcia-Carrasquillo R. Doxycycline-induced cholestatic liver injury. Clin J Gastroenterol. 2021;14:1503-1510.. (43 year old woman developed fatigue, fever, and nausea beginning 3 days after starting doxycycline and, despite stopping the drug, was followed by dark urine and jaundice [bilirubin 12.5 mg/dL, ALT 83 U/L, Alk P 339 U/L], jaundice clearing in 1-2 months and all tests normal at 5 months: Case 2). 34228348
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. (Analysis of the spontaneous reports of drug-induced liver injury to the FDA adverse event reporting system [FAERS] made between 2004 and 2020 identified 1435 cases, most due to minocycline [n=547], doxycycline [545], and tigecycline [288] with increasing numbers in recent years). 35364753
Nikolajevic N, Nikolajevic M, Pantic I, Korica B, Kotseva M, Alempijevic T, Jevtic D, et al. Drug-induced liver injury due to doxycycline: a case report and review of literature. Cureus. 2024;16:e59687. (28 year old man with Lyme disease developed nausea 5 days after starting doxycycline [100 mg twice daily] with bilirubin 0.7 mg/dL, ALT 758 U/L, Alk P normal, INR 1.1 and improvement on stopping doxycycline and switching to amoxicillin, with normal liver tests one month later). 38836151
Torgersen J, Mezochow AK, Newcomb CW, Carbonari DM, Hennessy S, Rentsch CT, Park LS, et al. Severe acute liver injury after hepatotoxic medication initiation in real-world data. JAMA Intern Med. 2024;184:943-952.. (Analysis of the US Veterans Administration electronic health records between 1999 and 2021 identified 1739 hospitalizations for acute liver injury suspected to be due to medications including doxycycline at an estimate rate of 1 per 3,700 persons per year of exposure). 38913369
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database only one [0.2%] was attributed to doxycycline). 38992407
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 6 cases [0.5%] attributed to doxycycline occurring at an estimated rate of 1 per 50,000 persons treated).
Reinhart JM. Drug-induced liver injury. Vet Clin North Am Small Anim Pract. 2025;55:717-730. (Extensive review of drug-induced liver injury in veterinary animals mentions that 39% of dogs and 19% of cats develop ALT elevations on doxycycline therapy but that clinically apparent injury must be rare). 40280782

## OTHER REFERENCE LINKS

1. Recent References on Doxycycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=doxycycline/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Doxycycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=doxycycline)